# Tofacitinib

## OVERVIEW

### Introduction

Tofacitinib is an oral, small molecule inhibitor of Janus kinases that is used to treat moderate-to-severe rheumatoid arthritis, psoriatic arthritis and inflammatory bowel disease. Tofacitinib is associated with transient and usually mild elevations in serum aminotransferase levels during therapy, but has yet to be linked to cases of clinically apparent acute liver injury.

### Background

Tofacitinib (tow" fa sye' ti nib) is an orally available, specific inhibitor of Janus-associated kinases (mainly JAK1 and JAK3) that is used to treat moderate-to-severe rheumatoid arthritis, psoriatic arthritis and inflammatory bowel disease. The Janus kinases are critical steps in immune activation as well as in hematopoiesis. The immunomodulatory effects of tofacitinib led to its evaluation in several autoimmune conditions including rheumatoid arthritis and psoriasis. In multiple, randomized controlled trials, tofacitinib was found to improve symptoms and signs of severe rheumatoid arthritis and psoriatic arthritis when used alone or in combination with other disease modifying antirheumatologic drugs (DMARDs). Tofacitinib was approved for use in rheumatoid arthritis in the United States in 2012. Subsequently, indications were expanded to psoriatic arthritis and inflammatory bowel disease. The Janus kinase inhibitors including tofacitinib are also being evaluated as therapy of the COVID-19, focusing upon alleviating the hyperinflammatory stages of advanced COVID-19 infection. At present, indications for tofacitinib are limited to moderate-to-severe rheumatoid arthritis and active psoriatic arthritis after failure or intolerance to methotrexate or other non-biological DMARDs, juvenile idiopathic arthritis with a polyarticular course, and moderately to severely active ulcerative colitis after failure of tumor necrosis factor (TNF) inhibitors. Tofacitinib is available in tablets of 5 and 10 mg under the brand name Xeljanz. The recommended dose is rheumatoid arthritis and psoriatic arthritis is 5 mg twice daily. For patients with active ulcerative colitis, an induction dose of 10 mg twice daily is recommended for the first three months. More recently, an extended release formulation of tofacitinib (Xeljanz XR, 11 and 22 mg tablets) that allows for once daily dosing has been made available. Common side effects of tofacitinib are neutropenia, headaches, diarrhea, fatigue, hypertension and symptoms of upper respiratory tract infection. Severe adverse events may include severe infections, reactivation of latent tuberculosis or herpes zoster, gastrointestinal perforation, venous and arterial thromboses, and de novo malignancies including Epstein-Barr virus related lymphoproliferative disorder.

### Hepatotoxicity

In large registration clinical trials, serum aminotransferase elevations occurred in 28% to 34% of tofacitinib treated subjects compared to 25% in comparator arms and 10% in placebo recipients. These elevations were typically mild and transient, but values above 3 times the upper limit of normal (ULN) occurred in 1% to 2% of patients on tofacitinib compared to less than 1% on placebo. The elevations occasionally led to early discontinuations, but more often resolved even without dose adjustment. In prelicensure studies, there were no instances of clinically apparent liver injury attributed to tofacitinib. Since approval and more wide scale availability of tofacitinib, there have been no published reports of hepatotoxicity associated with its use but a proportion of patients do develop serum aminotransferase elevations which in some cases leads to drug discontinuation. While other Janus kinase inhibitors such as ruxolitinib have been associated with episodes of reactivation of hepatitis B, spontaneous reports of clinically apparent reactivation of hepatitis during tofacitinib therapy have not been reported. On the other hand, retrospective studies on patients with HBsAg and inactive liver disease who were treated with tofacitinib have been reported to develop rising levels of HBV DNA and modest elevations in serum aminotransferase levels without symptoms. In contrast, studies of patients with anti-HBc without HBsAg in serum have shown no evidence of HBV DNA rises and appearance of HBsAg. Thus, reactivation of hepatitis B during therapy can occur, although it is generally mild and self-limited in course. Whether reactivation of hepatitis B can arise after therapy of susceptible patients with tofacitinib for severe COVID-19 pneumonia is unknown, but there have been no such reports to date.

Likelihood score: E* (suspected but unproven rare cause of clinically apparent liver injury with the potential to cause reactivation of hepatitis B).

### Mechanism of Injury

The causes of serum enzyme elevations during tofacitinib therapy are not known. Tofacitinib is metabolized in the liver largely through the CYP 3A4 pathway and liver injury may be related to production of a toxic or immunogenic intermediate. Because it is a substrate for CYP 3A4, tofacitinib is susceptible to drug-drug interactions with agents that inhibit or induce this specific hepatic microsomal activity. Tofacitinib is a potent immunomodulatory agent and appears to be capable of causing reactivation of hepatitis B.

### Outcome and Management

Monitoring of serum aminotransferase levels is recommended for patients starting tofacitinib. Serum aminotransferase elevations above 5 times the upper limit of normal (if confirmed) or any elevations accompanied by jaundice or symptoms should lead to dose reduction or temporary cessation. There are no data to suggest a cross reactivity in risk for hepatic injury between tofacitinib and other kinase inhibitors or biologic or nonbiologic DMARDs. Because tofacitinib is capable of inducing reactivation of hepatitis B, patients starting long term therapy with tofacitinib should be screened for HBsAg and anti-HBc. Patients with preexisting HBsAg in serum should undergo evaluation and prophylaxis against reactivation of HBV using potent oral antiviral agents, such as tenofovir or entecavir. Those with anti-HBc without HBsAg or HBV DNA should be monitored for evidence of infection and treated if there is de novo appearance of HBsAg or HBV DNA.

Drug Class: Antirheumatic Agents, Protein Kinase Inhibitors, COVID-19 Drugs

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Tofacitinib – Xeljanz®

DRUG CLASS

Antirheumatic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Tofacitinib)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Ruxolitinib | 941678-49-5 | C17-H18-N6
Tofacitinib | 477600-75-2 | C16-H20-N6-O

## ANNOTATED BIBLIOGRAPHY

References updated: 30 August 2022

Zimmerman HJ. Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of protein kinase inhibitors such as tofacitinib).
DeLeve LD. Erlotinib. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 556. (Review of hepatotoxicity of cancer chemotherapeutic agents discusses several kinase inhibitors including imatinib, gefitinib, erlotinib and crizotinib, but not tofacitinib).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway-targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics; tofacitinib is not discussed specifically).
Kremer JM, Bloom BJ, Breedveld FC, Coombs JH, Fletcher MP, Gruben D, Krishnaswami S, et al. (2009). The safety and efficacy of a JAK inhibitor in patients with active rheumatoid arthritis: Results of a double-blind, placebo-controlled phase IIa trial of three dosage levels of CP-690,550 versus placebo. Arthritis Rheum. (Among 264 patients with rheumatoid arthritis treated with tofacitinib [5, 15 or 30 mg] or placebo twice daily for 6 weeks, symptomatic improvements occurred within 1 week of starting tofacitinib and the most common adverse events were headache and nausea; no mention of ALT elevations or hepatotoxicity).
Tanaka Y, Suzuki M, Nakamura H, Toyoizumi S, Zwillich SH, Tofacitinib Study Investigators. (2011). Phase II study of tofacitinib (CP-690,550) combined with methotrexate in patients with rheumatoid arthritis and an inadequate response to methotrexate. Arthritis Care Res (Hoboken). (Among 140 patients with rheumatoid arthritis receiving methotrexate treated with tofacitinib [1, 3, 5 or 10 mg] or placebo twice daily for 12 weeks, ALT elevations occurred in 19% of patients on tofacitinib [vs 4% on placebo], but levels were above 3 times ULN in only 3% and no patient developed clinically apparent liver injury).
Papp KA, Menter A, Strober B, Langley RG, Buonanno M, Wolk R, Gupta P, et al. (2012). Efficacy and safety of tofacitinib, an oral Janus kinase inhibitor, in the treatment of psoriasis: a Phase 2b randomized placebo-controlled dose-ranging study. Br J Dermatol. (Among 197 patients with plaque psoriasis treated with tofacitinib [2, 5 or 15 mg] or placebo twice daily for 12 weeks, adverse event rates were similar with tofacitinib and placebo; one patient [0.7%] discontinued therapy because of ALT elevations).
Kremer JM, Cohen S, Wilkinson BE, Connell CA, French JL, Gomez-Reino J, Gruben D, et al. (2012). A phase IIb dose-ranging study of the oral JAK inhibitor tofacitinib (CP-690,550) versus placebo in combination with background methotrexate in patients with active rheumatoid arthritis and an inadequate response to methotrexate alone. Arthritis Rheum. (Among 507 patients with rheumatoid arthritis with an inadequate response to methotrexate treated with tofacitinib in several doses or placebo for 12 weeks, clinical responses were better with tofacitinib and common adverse events included diarrhea, headache and infections; ALT elevations above 3 times ULN occurring most frequently with the higher doses of tofacitinib, leading to 3 patients discontinuing therapy early).
Fleischmann R, Cutolo M, Genovese MC, Lee EB, Kanik KS, Sadis S, Connell CA, et al. (2012). Phase IIb dose-ranging study of the oral JAK inhibitor tofacitinib (CP-690,550) or adalimumab monotherapy versus placebo in patients with active rheumatoid arthritis with an inadequate response to disease-modifying antirheumatic drugs. Arthritis Rheum. (Among 384 patients with rheumatoid arthritis treated with tofacitinib in varying doses or adalimumab or placebo for 12 weeks, ALT elevations occurred in 17% on tofacitinib vs 20% on placebo and were above 3 times ULN in 1% vs 0%).
van Vollenhoven RF, Fleischmann R, Cohen S, Lee EB, García Meijide JA, Wagner S, Forejtova S, et al., ORAL Standard Investigators. (2012). Tofacitinib or adalimumab versus placebo in rheumatoid arthritis. N Engl J Med. (Among 717 patients with rheumatoid arthritis on methotrexate treated with tofacitinib [5 or 10 mg] or adalimumab or placebo for 52 weeks, clinical response rates were higher for tofacitinib [52-53%] than placebo [28%] and adverse events were more common [with two cases of pulmonary tuberculosis]; ALT elevations during the first 3 months occurred in 26% on tofacitinib vs 17% on placebo).
Fleischmann R, Kremer J, Cush J, Schulze-Koops H, Connell CA, Bradley JD, Gruben D, et al., ORAL Solo Investigators. (2012). Placebo-controlled trial of tofacitinib monotherapy in rheumatoid arthritis. N Engl J Med. (Among 611 patients with rheumatoid arthritis treated with tofacitinib [5 or 10 mg] or placebo twice daily for 3 months, clinical response rates were higher with tofacitinib, and adverse events included headache, infections, neutropenia and increases in serum cholesterol; ALT elevations above 3 times ULN occurred during the first 3 months in <1% of both groups).
Kremer J, Li ZG, Hall S, Fleischmann R, Genovese M, Martin-Mola E, Isaacs JD, et al. (2013). Tofacitinib in combination with nonbiologic disease-modifying antirheumatic drugs in patients with active rheumatoid arthritis: a randomized trial. Ann Intern Med. (Among 795 patients with rheumatoid arthritis [and an inadequate response to DMARDs] treated with tofacitinib [5 or 10 mg] or placebo twice daily for 3 months with extension of active treatment for 1 year, 3 tofacitinib treated patients stopped therapy early because of ALT or AST elevations, but there were no reports of clinically apparent liver injury).
Burmester GR, Blanco R, Charles-Schoeman C, Wollenhaupt J, Zerbini C, Benda B, Gruben D, et al., ORAL Step investigators. (2013). Tofacitinib (CP-690,550) in combination with methotrexate in patients with active rheumatoid arthritis with an inadequate response to tumour necrosis factor inhibitors: a randomised phase 3 trial. Lancet. (Among 399 patients with rheumatoid arthritis [and an inadequate response to antitumor necrosis factor agents] treated with tofacitinib [5 or 10 mg] or placebo twice daily for 3 months, ALT elevations occurred in 17% on tofacitinib vs 13% on placebo, but were above 3 times ULN in 0.8% vs 0% and no patient developed clinically apparent liver injury).
(2013). Tofacitinib (Xeljanz) for rheumatoid arthritis. Med Lett Drugs Ther. (Concise review of the mechanism of action, pharmacology, efficacy, safety and costs of tofacitinib shortly after its approval for in the US, mentions that elevations in ALT and AST have occurred with therapy and that “liver enzymes should be monitored regularly”).
Shah RR, Morganroth J, Shah DR. (2013). Hepatotoxicity of tyrosine kinase inhibitors: clinical and regulatory perspectives. Drug Saf. (Review of the hepatotoxicity of 18 tyrosine kinase inhibitors approved for use in cancer in the US as of 2013; tofacitinib is not discussed).
Spraggs CF, Xu CF, Hunt CM. (2013). Genetic characterization to improve interpretation and clinical management of hepatotoxicity caused by tyrosine kinase inhibitors. Pharmacogenomics. (Review of genetic associations of serum ALT and bilirubin elevations during therapy with tyrosine kinase inhibitors focusing on lapatinib and pazopanib; tofacitinib is not mentioned).
Wollenhaupt J, Silverfield J, Lee EB, Curtis JR, Wood SP, Soma K, Nduaka CI, et al. (2014). Safety and efficacy of tofacitinib, an oral Janus kinase inhibitor, for the treatment of rheumatoid arthritis in open-label, longterm extension studies. J Rheumatol. (Among 4102 patients with rheumatoid arthritis treated with tofacitinib for up to 5 years in 2 open label studies following participation in placebo controlled trials, 21% of patients discontinued treatment and serious adverse events occurred in 15%, with ALT elevations above 3 times ULN in 48 patients [1.2%], 22 discontinuing treatment for this reason, and one patient having persistent ALT elevations and later diagnosis of autoimmune hepatitis requiring corticosteroid therapy).
Papp KA, Menter MA, Abe M, Elewski B, Feldman SR, Gottlieb AB, Langley R, et al. (2015). OPT Pivotal 1 and OPT Pivotal 2 investigators. Tofacitinib, an oral Janus kinase inhibitor, for the treatment of chronic plaque psoriasis: results from two randomized, placebo-controlled, phase III trials. Br J Dermatol. (Among 1861 patients with plaque psoriasis treated with tofacitinib [5 or 10 mg] or placebo twice daily for 16 weeks, higher rates of improvement occurred with tofacitinib [42-59%] than placebo [9-11%], while adverse event rates were similar overall; ALT elevations above 3 times ULN occurred in 0.6% vs 0.2% of patients).
Tanaka Y, Takeuchi T, Yamanaka H, Nakamura H, Toyoizumi S, Zwillich S. (2015). Efficacy and safety of tofacitinib as monotherapy in Japanese patients with active rheumatoid arthritis: a 12-week, randomized, phase 2 study. Mod Rheumatol. (Among 317 Japanese patients with rheumatoid arthritis treated with tofacitinib [1, 3, 5, 10 or 15 mg] or placebo twice daily for 12 weeks, ALT elevations above 3 times ULN occurred in 0-1.9% of tofacitinib vs 3.8% of placebo recipients and led to early discontinuation of therapy in one tofacitinib treated subject).
Cohen SB, Koenig A, Wang L, Kwok K, Mebus CA, Riese RJ, Fleischmann R. (2016). Efficacy and safety of tofacitinib in US and non-US rheumatoid arthritis patients: pooled analyses of phase II and III. Clin Exp Rheumatol. (Pooled data on side effects from more than 3000 patients with rheumatoid arthritis focused largely on respiratory infections, diarrhea and edema; there were no cases of tuberculosis, lymphoma or serious herpes zoster infections; no mention of hepatotoxicity or reactivation of hepatitis B).
Charles-Schoeman C, Burmester G, Nash P, Zerbini CA, Soma K, Kwok K, Hendrikx T, et al. (2016). Efficacy and safety of tofacitinib following inadequate response to conventional synthetic or biological disease-modifying antirheumatic drugs. Ann Rheum Dis. (Among 3517 patients with rheumatoid arthritis participating in 9 placebo controlled trials of tofacitinib, response as well as serious adverse event rates were similar among those who had never received and those who had an inadequate response to a previous course of a biological DMARD; no mention of ALT elevations or hepatotoxicity).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 5 cases were attributed to drugs for rheumatoid arthritis: all 5 due to leflunomide and none to tofacitinib).
Papp KA, Krueger JG, Feldman SR, Langley RG, Thaci D, Torii H, Tyring S, et al. (2016). Tofacitinib, an oral Janus kinase inhibitor, for the treatment of chronic plaque psoriasis: Long-term efficacy and safety results from 2 randomized phase-III studies and 1 open-label long-term extension study. J Am Acad Dermatol. (Among 1861 patients with plaque psoriasis treated with tofacitinib or placebo for 16 weeks who were then all treated for up to 24 months, initial responses were maintained for the duration of treatment and risk for adverse events did not increase over time, although there were eventually 67 cases of herpes zoster and 5 deaths, none of which were considered related to tofacitinib; no mention of hepatotoxicity or reactivation of hepatitis B).
Chen MH, Chen MH, Liu CY, Tsai CY, Huang DF, Lin HY, Lee MH, et al. (2017). Hepatitis B virus reactivation in rheumatoid arthritis patients undergoing biologics treatment. J Infect Dis. (Among 123 HBsAg positive patients with rheumatoid arthritis not given antiviral prophylaxis, 30 [24%] developed HBV reactivation, including 18 of 51 on corticosteroids and 12 of 36 [33%] on biologic agents such as anti-TNF (8 of 26: 31%]] and rituximab [3 of 6: 50%]).
Fleischmann R, Mysler E, Hall S, Kivitz AJ, Moots RJ, Luo Z, DeMasi R, et al., ORAL Strategy investigators. (2017). Efficacy and safety of tofacitinib monotherapy, tofacitinib with methotrexate, and adalimumab with methotrexate in patients with rheumatoid arthritis (ORAL Strategy): a phase 3b/4, double-blind, head-to-head, randomised controlled trial. Lancet. (Among 1146 patients with rheumatoid arthritis treated with tofacitinib alone or with methotrexate or adalimumab for 1 year, response rates were slightly higher with addition of methotrexate [46%] and adalimumab [44%] compared to tofacitinib alone, as were ALT elevations above 3 times ULN [4% and 4% vs 2%], and 2 patients developed "drug-induced liver injury").
Zhang J, Tsai TF, Lee MG, Zheng M, Wang G, Jin H, Gu J, et al. (2017). The efficacy and safety of tofacitinib in Asian patients with moderate to severe chronic plaque psoriasis: A Phase 3, randomized, double-blind, placebo-controlled study. J Dermatol Sci. (Among 266 Asian patients with plaque psoriasis treated with tofacitinib or placebo for 16 weeks and then "advanced" to tofacitinib, only 3 patients had ALT elevations above 3 times ULN and none developed symptoms or jaundice).
Panés J, Sandborn WJ, Schreiber S, Sands BE, Vermeire S, D'Haens G, Panaccione R, et al. (2017). Tofacitinib for induction and maintenance therapy of Crohn's disease: results of two phase IIb randomised placebo-controlled trials. Gut. (Among 280 patients enrolled in 8 week placebo controlled trials of 2 doses of tofacitinib for Crohn’s disease, 180 enrolled in a maintenance trial for up to 24 weeks; total and severe adverse event rates were similar in all groups; no mention of ALT elevations or hepatotoxicity or of reactivation of hepatitis B).
Cohen SB, Tanaka Y, Mariette X, Curtis JR, Lee EB, Nash P, Winthrop KL, et al. (2017). Long-term safety of tofacitinib for the treatment of rheumatoid arthritis up to 8.5+ years: integrated analysis of data from the global clinical trials. Ann Rheum Dis. (Analysis of long term safety of tofacitinib based upon pooled data on 6194 patients with rheumatoid arthritis found incidence rates of herpes zoster to be 3.9 per 100 patient-years, 2.7 for serious infections and 0.2 for tuberculosis, but there were no instances of reactivation of hepatitis B mentioned).
Cohen S, Curtis JR, DeMasi R, Chen Y, Fan H, Soonasra A, Fleischmann R. (2018). Worldwide, 3-year, post-marketing surveillance experience with tofacitinib in rheumatoid arthritis. Rheumatol Ther. (Postmarketing reports of adverse events over a 3 year period identified 4352 serious adverse events, the most frequent of which were infections [n=827, 2.6 per 100 patient-yrs] and hepatobiliary disorders were rare [n=41, 0.12 per 100 patient-yrs], but no details provided).
Valenzuela F, Korman NJ, Bissonnette R, Bakos N, Tsai TF, Harper MK, Ports WC, et al. (2018). Tofacitinib in patients with moderate to severe chronic plaque psoriasis: long-term safety and efficacy in an open-label extension study. Br J Dermatol. (Among 2867 patients treated with tofacitinib for a median of 3 years, adverse events arose in 2366 [83%] patients, including 176 [6%] with herpes zoster and 1 with tuberculosis, but none with reactivation of hepatitis B or clinically apparent liver injury with jaundice).
Chen YM, Huang WN, Wu YD, Lin CT, Chen YH, Chen DY, Hsieh TY. (2018). Reactivation of hepatitis B virus infection in patients with rheumatoid arthritis receiving tofacitinib: a real-world study. Ann Rheum Dis. (Among 116 Taiwanese patients with rheumatoid arthritis treated with tofacitinib at a single center over a 2 year period, 81 had serologic evidence of ongoing or previous HBV infection; 2 of the 6 HBsAg positive [2 received prophylaxis] but none of the 75 with anti-HBc without HBsAg developed evidence of reactivation [de novo appearance of HBV DNA], which triggered rapid initiation of therapy with entecavir).
Zhang Z, Deng W, Wu Q, Sun L. (2019). Tuberculosis, hepatitis B and herpes zoster in tofacitinib-treated patients with rheumatoid arthritis. Immunotherapy. (Systematic review of the literature of rates of tuberculosis, HBV and herpes zoster in patients treated in clinical trials of long term tofacitinib [19,406 patient years] found that most studies excluded patients with chronic hepatitis B or C, but studies from Taiwan [Chen et al, 2018] reported HBV reactivation in 2 of 4 subjects with HBsAg [not given prophylaxis] and 1.7% of patients overall, while rates of tuberculosis on long-term tofacitinib were 0.17 and herpes zoster were 3.9 per 100 patient-years).
(2019). Drugs for psoriatic arthritis. Med Lett Drugs Ther. (Concise review of the mechanism of action, relative clinical efficacy, safety and costs of drugs in use for therapy of psoriatic arthritis including NSAIDS, apremilast, TNF inhibitors, ustekinumab, secukinumab, ixekizumab, abatacept, and tofacitinib mentions that tofacitinib can cause aminotransferase elevations and has been linked to venous thromboses that can be severe and even fatal).
Cohen SB, Tanaka Y, Mariette X, Curtis JR, Lee EB, Nash P, Winthrop KL, et al. (2020). Long-term safety of tofacitinib up to 9.5 years: a comprehensive integrated analysis of the rheumatoid arthritis clinical development programme. RMD Open. (Among 7061 adults with rheumatoid arthritis treated with tofacitinib for a median of 3.1 years, 782 [11.1%] developed herpes zoster, 576 [8.2%] had serious infections, 38 [05%] developed active tuberculosis and venous thrombotic events in 59 [1%]; no mention of ALT elevations or hepatoxicity).
Palasik BN, Wang H. (2021). Tofacitinib, the first oral janus kinase inhibitor approved for adult ulcerative colitis. J Pharm Pract. (Summary of the structure, mechanism of action, pharmacology, clinical efficacy and safety of tofacitinib).
Deepak P, Alayo QA, Khatiwada A, Lin B, Fenster M, Dimopoulos C, Bader G, et al. (2021). Safety of tofacitinib in a real-world cohort of patients with ulcerative colitis. Clin Gastroenterol Hepatol. (Among 260 patients with ulcerative colitis or Crohn’s disease treated with tofacitinib and followed for a median of 6 months and monitored for side effects, 15% had at least one adverse event included 13.5% with infection; 5 had herpes zoster and 2 had venous thrombotic events; no mention of ALT elevations or hepatotoxicity).
Nash P, Coates LC, Kivitz AJ, Mease PJ, Gladman DD, Covarrubias-Cobos JA, FitzGerald O, et al. (2020). Safety and efficacy of tofacitinib in patients with active psoriatic arthritis: interim analysis of OPAL Balance, an open-label, long-term extension study. Rheumatol Ther. (Among 686 patients with psoriatic arthritis treated with tofacitinib for up to 3 years, herpes zoster developed in 19 patients [2.8%], serious infections in 11 [1.6%] and ALT elevations in 27 [4%], but no patient developed clinically apparent liver injury with jaundice).
Serling-Boyd N, Mohareb AM, Kim AY, Hyle EP, Wallace ZS. (2021). The use of tocilizumab and tofacitinib in patients with resolved hepatitis B infection: a case series. Ann Rheum Dis. (Among 20 US patients with rheumatoid arthritis who were positive for anti-HBc without HBsAg in serum and who were treated with tocilizumab [n=16] and/or tofacitinib [n=8], none developed evidence of reactivation of hepatitis B, however routine monitoring for HBV DNA was not done).
Watanabe R, Hashimoto M, Morinobu A. Correspondence on 'The use of tocilizumab and tofacitinib in patients with resolved hepatitis B infection: a case series'. 2020 Nov 3: annrheumdis-2020-219270. (Letter in response to Serling-Boyd [2020] suggesting use of routine screening for hepatitis B markers in patients receiving advanced immunotherapies such as tocilizumab and tofacitinib).
Jacobs J, Clark-Snustad K, Lee S. (2020). Case report of a SARS-CoV-2 infection in a patient with ulcerative colitis on tofacitinib. Inflamm Bowel Dis. (33 year old woman with ulcerative colitis had a mildly symptomatic, self-limited case of COVID-19 and no worsening of her gastrointestinal disease despite continuing tofacitinib during the infection).
Peterson D, Damsky W, King B. (2020). The use of Janus kinase inhibitors in the time of severe acute respiratory syndrome coronavirus 2 (SARS-CoV-2). J Am Acad Dermatol. (Letter expressing caution about use of Janus kinase inhibitors during COVID 19 infection based upon their mechanism of action in blocking intracellular signaling pathways mediated by Janus kinases which might block normal immunologic function, but also mentioning 3 patients with alopecia areata who developed COVID-19 infection while on an inhibitor and had a relative mild, normal course of infection).
Satarker S, Tom AA, Shaji RA, Alosious A, Luvis M, Nampoothiri M. (2021). JAK-STAT pathway inhibition and their implications in COVID-19 therapy. Postgrad Med. (Review of the mechanism of action and pleomorphic activities of Janus kinase inhibitors and their possible role in treating severe COVID-19 infection which is often accompanied by high levels of proinflammatory cytokines [cytokine storm], with listing of ongoing trials including several of tofacitinib).
Wong HS, Guo CL, Lin GH, Lee KY, Okada Y, Chang WC. (2021). Transcriptome network analyses in human coronavirus infections suggest a rational use of immunomodulatory drugs for COVID-19 therapy. Genomics. (Analysis of the temporal pattern of upregulation of genes in cells infected with SARS-CoV-2 suggest that medications most likely to affect these changes include among others dexamethasone, baricitinib, tofacitinib, sarilumab, ritonavir, naproxen, avelumab, durvalumab and atezolizumab).
Gatti M, Turrini E, Raschi E, Sestili P, Fimognari C. (2021). Janus kinase inhibitors and coronavirus disease (COVID)-19: rationale, clinical evidence and safety issues. Pharmaceuticals (Basel). (Review of the theoretic basis for use of JAK inhibitors in COVID-19 disease, clinical efficacy and safety of baricitinib and ruxolitinib mentions rare instances of ALT elevations and one case of drug-induced liver injury).
Raghuvanshi R, Bharate SB. (2022). Recent developments in the use of kinase inhibitors for management of viral infections. J Med Chem. (Review of the kinase inhibitors approved for use in the US, their mechanisms of action and possible role in inhibiting viral replication).
Maslennikov R, Ivashkin V, Vasilieva E, Chipurik M, Semikova P, Semenets V, Russkova T, et al. (2021). Tofacitinib reduces mortality in coronavirus disease 2019 Tofacitinib in COVID-19. Pulm Pharmacol Ther. (Among 32 patients with COVID-19 and CRP elevations treated with tofacitinib for 5 days, the mortality rate was 17% and adverse events included ALT elevations in 59%, above 3 times ULN in 25% and above 10 times ULN in 6%).
Huang JX, Zhang LJ. (2020). Successful treatment of tofacitinib in a case with rheumatoid arthritis who experienced hepatitis B virus reactivation induced by tocilizumab and recovered from entecavir rescue therapy. Arch Rheumatol. (77 year old man with rheumatoid arthritis and HBsAg with normal ALT and low levels of HBV DNA was treated with tocilizumab and developed rises in HBV DNA [10 million IU/mL] and ALT [221 U/L], which responded to entecavir and did not recur when tofacitinib was started).
Wang ST, Tseng CW, Hsu CW, Tung CH, Huang KY, Lu MC, Lai NS. (2021). Reactivation of hepatitis B virus infection in patients with rheumatoid arthritis receiving tofacitinib. Int J Rheum Dis. (Among 98 patients with rheumatoid arthritis with HBsAg in serum [n=8] or anti-HBc without HBsAg [n=64] treated with tofacitinib at a single Taiwanese hospital between 2015 and 2020, two with HBsAg and two without developed virologic evidence of HBV reactivation [after 11 to 57 months], but all recovered spontaneously [without antiviral therapy], none developed symptoms or jaundice and only one had transient ALT elevations [peak 104 U/L]).
Rodríguez-Tajes S, Miralpeix A, Costa J, López-Suñé E, Laguno M, Pocurull A, Lens S, et al. (2021). Low risk of hepatitis B reactivation in patients with severe COVID-19 who receive immunosuppressive therapy. J Viral Hepat. (Among 61 patients with severe COVID-19 who received immunomodulatory therapy [corticosteroids in 100%, tocilizumab in 72%, baricitinib in 3%] and were HBsAg negative but anti-HBc positive, 38 were given antiviral prophylaxis with entecavir and 23 were not, but none developed HBV reactivation, although 2 [no prophylaxis, anti-HBs negative] developed transient low levels of HBV DNA [<10 IU/mL] without aminotransferase elevations).
Mazza S, Soro S, Verga MC, Elvo B, Ferretti F, Cereatti F, Drago A, et al. (2021). Liver-side of inflammatory bowel diseases: Hepatobiliary and drug-induced disorders. World J Hepatol. (Review of the hepatic manifestations and complications of inflammatory bowel disease including sclerosing cholangitis, gallstones, nonalcoholic hepatitis, portal vein thrombosis and drug induced liver injury caused by sulfasalazine, azathioprine, thioguanine, methotrexate, TNF inhibitors and tofacitinib mentions that no case of clinical apparent liver injury has been reported with tofacitinib therapy).
Hoisnard L, Lebrun-Vignes B, Maury S, Mahevas M, El Karoui K, Roy L, Zarour A, et al. (2022). Adverse events associated with JAK inhibitors in 126,815 reports from the WHO pharmacovigilance database. Sci Rep. (Among 126,815 individual case safety reports on ruxolitinib, tofacitinib and baricitinib made to the WHO pharmacovigilance registry, infections were most frequent including viral, fungal, bacterial and mycobacterial complications while there was no increase in hepatobiliary reports).
Mohareb AM, Patel NJ, Fu X, Kim AY, Wallace ZS, Hyle EP. (2022). Screening for hepatitis B virus prior to initiating tocilizumab and tofacitinib in patients with rheumatic diseases: a cross-sectional study. J Rheumatol. (Survey of 678 patients starting tocilizumab and 307 tofacitinib therapy found that only 29% and 24% were tested for HBsAg, anti-HBc and anti-HBs before starting therapy [despite CDC recommendations] and an average of 30% had inappropriate tests done).
Avni-Biron I, Bar-Gil Shitrit A, Koslowsky B, Levartovsky A, Kopylov U, Weisshof R, Aviv Cohen N, et al. (2022). Short-term effectiveness and safety of tofacitinib in ulcerative colitis - real world data from tertiary medical centers in Israel. Dig Liver Dis. (Among 73 patients with ulcerative colitis treated with tofacitinib in general medical practice in Israel, the response rate was 65% and 17 patients had adverse events including 2 with herpes zoster [2.7%], while there were no reports of elevations in liver enzymes).
Kostik MM, Raupov RK, Suspitsin EN, Isupova EA, Gaidar EV, Gabrusskaya TV, Kaneva MA, et al. (2022). The safety and efficacy of tofacitinib in 24 cases of pediatric rheumatic diseases: single centre experience. Front Pediatr. (Among 24 children with juvenile rheumatoid arthritis, autoinflammatory diseases or dermatomyositis treated with tofacitinib for 6 months or more, complete responses occurred in half and adverse events were uncommon, 2 children had liver enzyme elevations that resolved without drug discontinuation).
D'Ardes D, Boccatonda A, Cocco G, Fabiani S, Rossi I, Bucci M, Guagnano MT, et al. (2022). Impaired coagulation, liver dysfunction and COVID-19: discovering an intriguing relationship. World J Gastroenterol. (Review of the hepatic manifestations of SARS-CoV-2 infection including direct effects of the viral infection, and secondary effects from cytokines as well as drug induced liver injury, mentioning the possible contribution of tofacitinib).
Yip TC, Gill M, Wong GL, Liu K. (2022). Management of hepatitis B virus reactivation due to treatment of COVID-19. Hepatol Int. (Review of published data on reactivation of hepatitis B caused by treatment of COVID focusing upon corticosteroids, baricitinib, tofacitinib, sarilumab and tocilizumab, which are capable of inducing reactivation when used in rheumatic disease, but have not been reported with their use for COVID-19 perhaps due to duration of therapy or the heightened immune activity of the viral infection).

## OTHER REFERENCE LINKS

1 Recent References on Tofacitinib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Tofacitinib+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Tofacitinib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Tofacitinib)